# Resmetirom

## OVERVIEW

### Introduction

Resmetirom is a thyroid hormone receptor beta (THR-β) agonist used in conjunction with diet and exercise in the therapy of nonalcoholic steatohepatitis (NASH) with moderate-to-severe fibrosis. Resmetirom therapy is associated with mild and transient serum aminotransferase elevations during the first month of therapy and with rare instances of acute liver injury which can be severe, but which reverses on drug discontinuation.

### Background

Resmetirom (res” me tir’ om) is a thyroid hormone receptor beta (THR-β) agonist used in the therapy of nonalcoholic steatohepatitis (NASH) with moderate-to-severe fibrosis. Resmetirom is a triiodothyronine (T3) mimetic agent that has preferential activity against the thyroid hormone receptor β (the predominant form found in the liver) and minimal activity against the receptor α (the major form found in heart and bone). In the liver, engagement of THR-β results in a decrease in lipogenesis, increase in fatty acid β oxidation, and decrease in hepatic fat accompanied by improvements in serum lipid profiles. In clinical trials in patients with NASH, resmetirom resulted in a decrease in hepatic fat as well as inflammation and cell injury. When given for 52 weeks, resmetirom was associated with a modest improvement in hepatic fibrosis. Resmetirom was approved in the United States in 2024 in conjunction with diet and exercise as therapy for adults with noncirrhotic NASH and moderate to advanced fibrosis. Similar trials in children and adolescents and in adults with cirrhosis are ongoing. Resmetirom is available in tablets of 60, 80, and 100 mg under the brand name Rezdiffra. The recommended daily dose is 80 mg for adults weighing less than 100 kg and 100 mg for those weighing 100 kg or more. Side effects of resmetirom include diarrhea, gastrointestinal discomfort, nausea, constipation, headache, dizziness, pruritus, and rash. Changes in thyroid function and decreases in sex hormones as well as follicle stimulating and luteinizing hormones can occur with therapy but do not appear to be clinically significant. Serious adverse events are rare but can include cholecystitis, pancreatitis, and hepatotoxicity.

### Hepatotoxicity

Mild, transient serum aminotransferase elevations develop in a high proportion of patients receiving resmetirom, generally within the first 4 weeks of therapy. These elevations are typically mild, self-limited, and not associated with symptoms or jaundice. Furthermore, these early changes were usually followed by a decrease in serum enzymes which were often within normal range 3 to 6 months later. These improvements in liver related enzymes correlated to some extent with the decrease in hepatic fat and histologic evidence of steatohepatitis. After 52 weeks of treatment, liver biopsies demonstrated resolution of NASH in 26% to 30% of patients. Whether these changes are sustained or increase with further therapy is not known. Therapy does not result in weight loss, and the improvements in hepatic histology and fibrosis may be lost once therapy is discontinued.

Analysis of liver tests from more than 1300 adults with NASH treated with resmetirom in doses of 80 or 100 mg daily for up to one year identified 2 patients with liver injury that was considered at least possibly due to resmetirom. The latency to initial onset was 2 and 3 months [ALT 236 U/L and 578 U/L, Alk P unknown and 64 U/L, bilirubin 0.6 and 1.1 mg/dL]. Both patients recovered completely within 1 to 2 months of stopping treatment. One patient was restarted on treatment and redeveloped liver injury within 28 days (ALT 3226 U/L, Alk P 140 U/L, bilirubin 10.9 mg/dL) that was more severe than the initial episode, but that resolved spontaneously within 2 months of stopping. In both cases, other diagnoses remained possible.

Likelihood score: D (possible rare cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism of liver injury from resmetirom is not known, but in the two reported cases, the injury appeared to be idiosyncratic and possibly immunologically mediated. Resmetirom is metabolized in part by the liver, predominantly by CYP 2C8 and concomitant use of strong CYP 2C8 inhibitors should be avoided.

### Outcome and Management

The product label for resmetirom recommends monitoring of liver tests during therapy, but does not provide guidance regarding timing or duration of monitoring. In view of the preliminary data on hepatic tests during resmetirom therapy, an appropriate approach would be testing at baseline and at 1, 2, 3 and 6 months, and every 6 months thereafter. Such testing also provides information on both the response of the liver disease as well as hepatic safety. Rise in serum aminotransferase levels by more than 3 times the ULN or three times baseline levels should lead to increased monitoring or temporary discontinuation until levels return to normal or baseline. Elevations of serum aminotransferase levels accompanied by symptoms or jaundice should lead to prompt discontinuation. There is no evidence of cross sensitivity to hepatotoxicity of resmetirom to other therapies used for NASH or liver disease.

Drug Class: Antilipemic Agents, Drugs for Liver Disease

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Resmetirom – Rezdiffra®

DRUG CLASS

Drugs for Liver Disease

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Resmetirom)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Resmetirom | 920509-32-6 | C17-H12-Cl2-N6-O4
Triiodothyronine | 6893-02-3 | C15-H12-I3-NO4

## ANNOTATED BIBLIOGRAPHY

References updated: 20 April 2024

Abbreviations: NASH, nonalcoholic steatohepatitis; THR, thyroid hormone receptor.

FDA. Resmetirom, Integrated Review. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2024/217785Orig1s000IntegratedR.pdf (FDA Summary of the data on resmetirom safety and efficacy submitted in support of the application for approval as therapy of nonalcoholic steatohepatitis (NASH) mentions that one probable and one possible case of drug induced liver disease arose among the 1333 patients included in two prospective trials used in the safety assessment; the probable case was in a 60 year old woman who developed liver test abnormalities 57 days after starting resmetirom [ALT 236 U/L, Alk P not done, bilirubin 0.4 mg/dL], which were slow to improve after stopping but rose from normal to high levels within a month of restarting resmetirom [ALT 3226 U/L, Alk P 140 U/L, bilirubin 10.9 mg/dL], which again fell to normal within 2 months of stopping without corticosteroid therapy).
Kelly MJ, Pietranico-Cole S, Larigan JD, Haynes NE, Reynolds CH, Scott N, Vermeulen J, et al. Discovery of 2-[3,5-dichloro-4-(5-isopropyl-6-oxo-1,6-dihydropyridazin-3-yloxy)phenyl]-3,5-dioxo-2,3,4,5-tetrahydro[1,2,4]triazine-6-carbonitrile (MGL-3196), a highly selective thyroid hormone receptor β agonist in clinical trials for the treatment of dyslipidemia. J Med Chem. 2014; 57: 3912-23. (Description of development of thyroid hormone [TH] mimetic chemical structures that had selective affinity for the β receptors [THR-β] which are found predominantly on hepatocytes, the optimal molecule [MGL-3196: resmetirom] showed 84% of the relative activity of T3 against the β receptor but only 49% of that against the α receptor, and in animal models it had cholesterol and triglyceride lowering activity with no cardiac toxicity or effect on the central thyroid axis). 24712661
Harrison SA, Bashir MR, Guy CD, Zhou R, Moylan CA, Frias JP, Alkhouri N, et al. Resmetirom (MGL-3196) for the treatment of non-alcoholic steatohepatitis: a multicentre, randomised, double-blind, placebo-controlled, phase 2 trial. Lancet. 2019; 394: 2012-2024. (Among 125 adults with biopsy confirmed non-cirrhotic NASH treated with resmetirom [60-80 mg daily] or placebo once daily for 36 weeks, MRI estimated liver fat fraction decreased more with resmetirom as did liver biopsy fat, inflammation and ballooning, and serum ALT and AST levels, while adverse events were similar in both groups except for symptoms of diarrhea and nausea; no mention of hepatotoxicity or liver injury with jaundice). 31727409
Harrison SA, Bashir M, Moussa SE, McCarty K, Pablo Frias J, Taub R, Alkhouri N. Effects of resmetirom on noninvasive endpoints in a 36-week phase 2 active treatment extension study in patients with NASH. Hepatol Commun. 2021; 5: 573-588. (Among 125 patients with NASH participating in a 36-week randomized placebo-controlled trial, 31 were enrolled in an open-label extension study for another 36 weeks which demonstrated a further decline in the liver fat fraction as well as improvements in serum aminotransferase levels and lipids, with no weight loss and no treatment related severe adverse events). 33860116
Karim G, Bansal MB. Resmetirom: an orally administered, small molecule, liver-directed, β-selective THR agonist for the treatment of non-alcoholic fatty liver disease and non-alcoholic steatohepatitis. touchREV Endocrinol. 2023; 19: 60-70. (Review of the mechanism of action and clinical effects of resmetirom, a relatively selective thyroid hormone receptor beta agonist, which decreases hepatic fat and lipotoxicity, and holds promise as therapy of NASH). 37313239
Harrison SA, Bedossa P, Guy CD, Schattenberg JM, Loomba R, Taub R, Labriola D, et al.; MAESTRO-NASH Investigators. A phase 3, randomized, controlled trial of resmetirom in NASH with liver fibrosis. N Engl J Med. 2024; 390: 497-509. (Among 966 patients with NASH and significant fibrosis treated with resmetirom [80 or 100 mg] or placebo once daily for 52 weeks, both doses were associated with a greater degree of improvement in liver histology [fibrosis, steatosis, ballooning and inflammation] than placebo, and while diarrhea, nausea, and vomiting were more frequent with resmetirom, they were transient and both total and serious adverse event rates were similar in the three groups and “there was no incidence of drug-induced liver injury”). 38324483

## OTHER REFERENCE LINKS

Recent References on Resmetirom: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Resmetirom+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

Trials on Resmetirom: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Resmetirom)